# Anagrelide

## OVERVIEW

### Introduction

Anagrelide is an antithrombotic and platelet reducing agent that is used to treat the thrombocythemia associated with myeloproliferative diseases. Anagrelide has had limited clinical use, but has not been linked to significant serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Anagrelide (an ag' re lide) is platelet reducing agent that is used to treat thrombocytosis due to myeloproliferative diseases. Its mechanism of action is not well defined, but it appears to inhibit the maturation and differentiation of megakaryocytes, and both synthesis and release of platelets as well as subsequent platelet aggregation. In addition, anagrelide inhibits phosphodiesterase-3 which causes vasodilation and may account for many of its side effects. In several open label trials, anagrelide was shown to reduce platelet counts in patients with thrombocythemia due to essential thrombocytosis and other myeloproliferative diseases. Severe thrombocythemia is associated with an increased risk of arterial and venous thromboses including transient ischemic attacks, stroke, myocardial infarction and other thrombotic ischemic conditions. Less commonly, thrombocytosis is associated with venous thromboses including deep vein thrombosis, pulmonary embolus and portal or splanchnic vein thrombosis. Anagrelide was approved for use in thrombocythemia due to myeloproliferative diseases in 1997, but is considered a second line agent, appearing to be less effective and less well tolerated than hydroxyurea. Anagrelide is available in capsules of 0.5 mg generically and under the brand name Agrylin. The typical initial dose is 0.5 mg daily, with subsequent gradual and monitored dose escalation based upon platelet counts and tolerance, not to exceed 10 mg daily or 2.5 mg in a single dose. It is often given in combination with aspirin. Side effects can include headache, dizziness, palpitations, fatigue, nausea, abdominal pain, dyspnea, cough, fever, edema, rash, chest pain and tachycardia. Rare, but potentially severe adverse reactions include arrhythmias, prolongation of the QTc interval, excessive bleeding and interstitial nephritis.

### Hepatotoxicity

In preregistration studies, anagrelide was not associated with serum enzyme elevations or with episodes of clinically apparent liver injury. Since its approval, there has been a single published abstract reporting progressive, ultimately fatal cholestasis after liver transplantation and use of anagrelide, but there have been no other published reports of anagrelide hepatotoxicity in the literature. In large, long term follow up studies there have been occasional instances of transient serum enzyme elevations without jaundice or symptoms. The product label for anagrelide mentions abnormal enzymes as an adverse event but not clinically apparent liver injury, hepatitis or jaundice. However, the general clinical experience with anagrelide has been limited.

Likelihood score: E* (unlikely, but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which anagrelide might cause serum aminotransferase elevations or liver injury is not known. The typical daily dose is low (1 to 10 mg), which may account for its relative lack of hepatotoxicity.

Drug Class: Antithrombotic Agents

Other Drugs in the Subclass (Primary Thrombocythemia): Hydroxyurea, Interferon alfa, Aspirin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Anagrelide – Generic, Agrylin®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Anagrelide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Anagrelide | 68475-42-3 | C10-H7-Cl2-N3-O | Anagrelide Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 July 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman, HJ. Hepatotoxicity. The adverse effects of drugs and other chemicals upon the liver. 2nd edition. Philadelphia. Lippincott, 1999. pp 673-708. (Textbook of drug induced liver injury published in 1999; does not discuss anagrelide).
Silverstein MN, Petitt RM, Solberg LA Jr, Fleming JS, Knight RC, Schacter LP. Anagrelide: a new drug for treating thrombocytosis. N Engl J Med 1988; 318: 1292-4. (Among 20 patients with thrombocytosis [>800,000] of various causes who were treated with anagrelide [1.5-4.0 mg daily] for up to 28 months, platelet counts decreased in 18 patients and side effects were mild: "except for the decrease in the platelet count, all other laboratory measurements remained normal throughout the study"). 3362187
Anagrelide, a therapy for thrombocythemic states: experience in 577 patients. Anagrelide Study Group. Am J Med 1992; 92: 69-76. (Among 577 patients with thrombocythemia treated with anagrelide for up to 5 years, side effects included hypotension, peripheral edema, palpitations, headache, dizziness, nausea, bloating, diarrhea, severe pancreatitis and pulmonary fibrosis; "one patient developed abnormalities in hepatocellular enzymes that resolved when the drug was discontinued and recurred on re-challenge"). 1731512
Anagrelide for essential thrombocythemia. Med Lett Drugs Ther 1997; 39 (1016): 120. (Concise review of the pharmacology, clinical efficacy, safety and costs of anagrelide shortly after its approval for thrombocytosis in the US; does not mention serum enzyme elevations or hepatotoxicity). 9422046
Lin S, Howell DN, Tuttle-Newhall JE, Heneghan MA. Cholestatic liver failure secondary to anagrelide. Am J Gastroenterol 2003; 98: S153. [Abstract, Not in PubMed] (48 year old man with a liver transplant for sclerosing cholangitis developed progressive cholestasis "shortly after" starting anagrelide and later died; no details provided).
Birgegård G, Björkholm M, Kutti J, Lärfars G, Löfvenberg E, Markevärn B, Merup M, et al. Adverse effects and benefits of two years of anagrelide treatment for thrombocythemia in chronic myeloproliferative disorders. Haematologica 2004; 89: 520-7. (Among 60 patients with thrombocythemia due to myeloproliferative diseases treated with anagrelide [0.5 to 5 mg daily] for 2 years, response rates were 67%, and side effects included palpitations [70%], headache [52%], nausea [35%], diarrhea [33%], edema [22%] and fatigue [23%]; no mention of ALT elevations and no reported hepatic severe adverse events). 15136214
Cacciola RR, Cipolla A, Di Francesco E, Giustolisi R, Cacciola E. Treatment of symptomatic patients with essential thrombocythemia: effectiveness of anagrelide. Am J Hematol 2005; 80: 81-3. (Analysis of platelet markers and coagulant activity in 17 patients with thrombocythemia treated with anagrelide [0.5 to 6 mg daily] showed resolution of symptoms of erythromelalgia [painful burning and erythematous extremities] in 9 patients and decrease in platelet aggregation and coagulant activity; no mention of ALT elevations or hepatotoxicity). 16138352
Harrison CN, Campbell PJ, Buck G, Wheatley K, East CL, Bareford D, Wilkins BS, et al.; United Kingdom Medical Research Council Primary Thrombocythemia 1 Study. Hydroxyurea compared with anagrelide in high-risk essential thrombocythemia. N Engl J Med 2005; 353: 33-45. (Among 809 patients with thrombocythemia on chronic aspirin therapy who were treated with either anagrelide or hydroxyurea for a median of 39 months, arterial thromboses and malignant transformation were less with hydroxyurea, while venous thromboses were less with anagrelide; slide effects of anagrelide included palpitations, abdominal pain and diarrhea and 4 patients had "abnormal liver function tests" compared to none on hydroxyurea). 16000354
Fruchtman SM, Petitt RM, Gilbert HS, Fiddler G, Lyne A; Anagrelide Study Group. Anagrelide: analysis of long-term efficacy, safety and leukemogenic potential in myeloproliferative disorders. Leuk Res 2005; 29: 481-91. (Long term follow up on a cohort of 3660 patients with thrombocytosis who were treated with anagrelide for up to 7 years found no evidence of increased risk of leukemia; no mention of clinically apparent liver injury or deaths from liver disease). 15755500
Emadi A, Spivak JL. Anagrelide: 20 years later. Expert Rev Anticancer Ther 2009; 9: 37-50. (Extensive review of the causes, clinical course and complications of thrombocythemia and role of anagrelide which is most effective in preventing venous thromboses; mentions serious cardiac, pulmonary and renal side effects, but not ALT elevations or clinically apparent hepatotoxicity). 19105705
Gugliotta L, Besses C, Griesshammer M, Harrison C, Kiladjian JJ, Coll R, Smith J, et al. Combination therapy of hydroxycarbamide with anagrelide in patients with essential thrombocythemia in the evaluation of Xagrid(R) efficacy and long-term safety study. Haematologica 2014; 99: 679-87. (Analysis of a large prospectively followed cohort of patients with thrombocythemia focusing upon 307 of the 3643 who were receiving the combination of anagrelide and hydroxycarbamide with discussion of complications of major complications, but does not mention liver related severe adverse events). 24334294
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 US medical centers, none were attributed to anagrelide). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Anagrelide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Anagrelide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Anagrelide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Anagrelide)